# Adagrasib

## OVERVIEW

### Introduction

Adagrasib is a small molecule inhibitor of the KRAS G12C mutant protein which is found in up to 13% of refractory cases of non-small cell lung cancer. Serum aminotransferase elevations are common during therapy with adagrasib, and a proportion of patients develop clinically apparent liver injury that can be severe.

### Background

Adagrasib (a” dah gras’ ib) is an orally available, small molecule inhibitor of the KRAS gene product that is a frequently mutated oncogene found in several forms of cancer, most commonly in non-small cell lung cancer (NSCLC). The KRAS (Kristen rat sarcoma viral oncogene homolog) G12C mutation produces a constituently active protein receptor (a member of the RAS GTPase family) that stimulates excessive cell growth. Adagrasib binds to and locks the abnormal receptor into an inactive conformation, thereby inhibiting cell growth and proliferation in tumor cell lines and experimental tumor models with the KRAS G12C mutation. In large open label trials, adagrasib was found to induce objective responses in 43% of patients with refractory NSCLC harboring the KRAS G12C mutation. Adagrasib was granted accelerated approval in the United States in 2022 for adults with NSCLC with documented KRAS G12C mutations, the second small molecule inhibitor approved for this indication (the first being sotorasib). Adagrasib remains under evaluation for other forms of cancer harboring KRAS G12C mutations. Adagrasib is available in tablets of 200 mg under the brand name Krazati. The recommended dose is 600 mg orally twice daily until disease progression or unacceptable toxicity. Side effects of adagrasib are common and arise in almost all treated patients, leading to dose interruptions in 77%, dose modifications in 28%, and permanent discontinuation in 13% of treated patients. Common side effects include diarrhea, nausea and vomiting, decreased appetite, abdominal pain, fatigue, musculoskeletal pain, cough, dyspnea, edema, leukopenia, anemia, renal impairment, hypokalemia, hyponatremia, and aminotransferase elevations. Uncommon but potentially severe adverse events include gastrointestinal bleeding and obstruction, severe diarrhea or nausea, QTc interval prolongation, hepatotoxicity, and interstitial lung disease.

### Hepatotoxicity

In the prelicensure clinical trials of adagrasib in patients with solid tumors harboring KRAS G12C mutations, liver test abnormalities were frequent although usually self-limited and mild. Some degree of ALT elevations arose in 28% to 46% of adagrasib treated patients and elevations above 5 times the upper limit of normal (ULN) were seen in 5% to 7%. In these trials that enrolled approximately 366 patients, adagrasib was discontinued early due to increased AST or ALT in 8% of patients. In addition, a small proportion of patients developed clinically apparent hepatotoxicity requiring adagrasib discontinuation. The liver test abnormalities had a median onset of 3 weeks after initiation of therapy. While serum aminotransferase elevations were occasionally quite high (5 to 20 times ULN), there were no accompanying elevations in serum bilirubin and no patient developed clinically apparent liver injury with jaundice. The product label for adagrasib recommends monitoring for routine liver tests before, at 3 week intervals during the first 3 months of therapy, and thereafter as clinically indicated.

Likelihood score: D (possible but infrequent cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of serum aminotransferase elevations from adagrasib is unknown, but the pattern of abnormalities suggests immune-mediated liver injury. Several retrospective analyses have found that significant ALT and AST elevations arise most frequently in patients receiving small molecule inhibitors who had received checkpoint inhibitor therapy (usually anti-PD-L1) within 3 months of starting. Furthermore, the histologic and clinical features of liver injury from tyrosine kinase and other small molecule inhibitors frequently resemble those of checkpoint inhibitors and a limited course of corticosteroids is often found to be beneficial.

Adagrasib is metabolized in the liver via the cytochrome P450 system, largely CYP 3A4, and is susceptible to drug-drug interactions with agents. Because of its known toxicity, drugs that inhibit or induce CYP 3A4 activity should be avoided or the dose of adagrasib should be adjusted according. Furthermore, drugs that are substrates of CYP 3A4 may be affected by concurrent treatment with adagrasib and should be avoided.

### Outcome and Management

The product label for adagrasib recommends monitoring for routine liver tests (ALT, AST, alkaline phosphatase, and bilirubin) before starting treatment, monthly for the first 3 months of treatment and as clinically indicated thereafter. The dose of adagrasib should be reduced, held, or permanently discontinued based upon the severity of liver test abnormalities as described in the product label. In patients with jaundice or symptoms of liver injury accompanying the serum aminotransferase elevations, adagrasib should be promptly discontinued and not restarted. Cross sensitivity to liver injury is uncommon among the antineoplastic, small molecule enzyme and receptor inhibitors, but there is no information on shared adverse event sensitivity of adagrasib with other similar small molecule inhibitors such as sotorasib.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Other Related Drugs: Sotorasib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Adagrasib – Krazati®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Adagrasib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Adagrasib | 2326521-71-3 | C32-H35-Cl-F-N7-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 04 October 2023

Abbreviations: KRAS, Kirsten rat sarcoma viral oncogene homolog; NSCLC, non-small cell lung cancer.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of small molecule enzyme and receptor inhibitors).
DeLeve LD. Kinase inhibitors. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents, does not discuss adagrasib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2023/216340Orig1s000MultidisciplineR.pdf (FDA website with initial multidiscipline clinical review of the safety and efficacy of adagrasib; states that the overall objective response rate was 43% in adults with NCSLC with KRAS p.G12C mutations and in a pooled safety review [n=366] most patients had at least one adverse event and 48% had a serious adverse event, 32% of patients had an ALT elevation, 5% were above 5 times ULN, and 1 patient [0.3%] developed anicteric drug induced liver injury, with signs of hypersensitivity that resolved on stopping therapy; there were cases of acute liver injury with jaundice or liver failure attributed with adagrasib).
Awad MM, Liu S, Rybkin II, Arbour KC, Dilly J, Zhu VW, Johnson ML, et al. Acquired resistance to KRASG12C inhibition in cancer. N Engl J Med. 2021;384:2382-2393. (Among 38 patients being treated with adagrasib for advanced solid tumors harboring a KRAS G12C mutation who had an initial response to therapy but subsequent relapse or progression [“acquired resistance”], further mutations in KRAS DNA were found in DNA from tumor tissue and from circulating tumor DNA, mostly secondary mutations or amplifications in KRAS, but also in other genes in the signaling pathways or with histologic transformations). 34161704
Jänne PA, Riely GJ, Gadgeel SM, Heist RS, Ou SI, Pacheco JM, Johnson ML, et al. Adagrasib in non-small-cell lung cancer harboring a KRASG12C mutation. N Engl J Med. 2022;387:120-131. (Among 116 adult with NSCLC harboring a KRAS G12C mutation treated with adagrasib [600 mg twice daily for a median of 13 months], 43% had an objective response, while adverse events occurred in all treated subjects leading to dose interruption or modification in 83% and permanent discontinuation in 16%, and with ALT elevations in 28% which were above 5 times ULN in 5%). 35658005
Ou SI, Jänne PA, Leal TA, Rybkin II, Sabari JK, Barve MA, Bazhenova L, et al. First-in-human phase I/IB dose-finding study of adagrasib (MRTX849) in patients with advanced KRAS/ G12C solid tumors (KRYSTAL-1). J Clin Oncol. 2022;40:2530-2538. (Among 25 patients with advanced KRAS G12C mutant solid tumors treated with adagrasib [600 mg twice daily], the objective response rate was 53% in NSCLC, while the adverse event rate was 92% with nausea in 76%, diarrhea 70%, vomiting 48%, fatigue 40% and ALT elevations in 20% which were above 5 times ULN in 5%). 35167329
Dhillon S. Adagrasib: first approval. Drugs. 2023;83:275-285. (Review of the mechanism of action, history of development, pharmacodynamics, clinical efficacy, and safety of adagrasib shortly after its initial approval in the US mentions that it has “manageable tolerability” with an overall adverse event rate of 97% with any liver test abnormality in 37% [among 366 treated patients] and ALT elevations in 28%, which were above 5 times the ULN in 4.3% and had a median time to onset of 3 weeks). 36763320
Adagrasib (Krazati) for NSCLC. Med Lett Drugs Ther. 2023;65:e17-e18. (Concise review of the mechanism of action, clinical efficacy, safety and costs of adagrasib, mentions that its effects were modest and that hepatotoxicity arose in more than 25% of patients, and that patients should be monitored for liver enzyme and bilirubin levels before and monthly for 3 months during therapy). 36651795
Chour A, Denis J, Mascaux C, Zysman M, Bigay-Game L, Swalduz A, Gounant V, et al. Brief report: severe sotorasib-related hepatotoxicity and non-liver adverse events associated with sequential anti-programmed cell death (ligand)1 and sotorasib therapy in KRASG12C-mutant lung cancer. J Thorac Oncol. 2023;18(10):1408-1415. (Among 102 adults with refractory advanced NSCLC and KRAS G12C mutations treated with sotorasib in France outside of clinical trials, 48 who had received check point inhibitor therapy with anti-PD-L1 immediately before sotorasib had higher rates of severe adverse events [50% vs 13%] and higher rates of ALT elevations above 5 times ULN [33% vs 11%], although no fatal instances of hepatotoxicity occurred). 37217096
Desai A, Rakshit S, Bansal R, Ashara Y, Potter A, Manochakian R, Lou Y, et al. Time from immune checkpoint inhibitor to sotorasib use correlates with risk of hepatotoxicity in non-small cell lung cancer: A brief report. Cancer Treat Res Commun. 2023;36:100743. (Among 31 patients with advanced, refractory KRAS G12C-mutated NSCLC treated with sotorasib, 10 [32%] developed ALT elevations above 5 times ULN during therapy, all 10 had received previous check point inhibitor therapy [usually anti-PD-L1] and rates of ALT elevations were higher in those receiving checkpoint inhibitors within 30 days [3 of 4: 75%], than 30-90 days [7 of 11:65%], or greater than 90 days [none of 13: 0%], suggesting that sotorasib triggers a delayed immune mediated hepatotoxicity from anti-PD-L1 therapy if given within 3 months of stopping). 37531736
Zhang J, Johnson M, Barve M, Bazhenova L, McCarthy M, Schwartz R, Horvath-Walsh E, Vet al. Practical guidance for the management of adverse events in patients with KRASG12C-mutated non-small cell lung cancer receiving adagrasib. Oncologist. 2023;28:287-296. (Review of the adverse events identified in trials of adagrasib and recommendations regarding monitoring and management based upon FDA labeling, mentions that liver enzymes [ALT, AST, Alk P] should be monitored every month for 3 months and that corticosteroid treatment can be considered for “significant hepatotoxicity”). 36892150

## OTHER REFERENCE LINKS

Recent References on Adagrasib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Adagrasib/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Adagrasib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Adagrasib)